# Venetoclax

## OVERVIEW

### Introduction

Venetoclax is an oral selective BCL-2 inhibitor and antineoplastic agent used in the therapy of refractory chronic lymphocytic leukemia (CLL). Venetoclax is associated with a low rate of transient serum enzyme elevations during therapy, but has not been implicated in cases of clinically apparent acute liver injury with jaundice. Venetoclax has potent immunosuppressive activity and may be capable of causing reactivation of hepatitis B.

### Background

Venetoclax (ven et' oh klax) is a small molecule inhibitor of BCL-2, an intracellular protein that inhibits apoptosis. BCL2 is overexpressed in cancer cells, particularly in chronic lymphocyte leukemia (CLL). Overexpression of BCL2 increases cancer cell survival and increases resistance to chemotherapy. Venetoclax binds directly to BCL2 and blocks its antiapoptotic activity, leading to programmed cell death in the malignant B cells. Venetoclax was found to have activity against refractory and relapsed CLL and was approved for use as an antineoplastic agent in the United States in 2016. Current indications are limited to therapy of previously treated patients with CLL and an accompanying 17p chromosomal deletion (which is associated with a poor prognosis and resistance to standard chemotherapy). Venetoclax is available as tablets of 10, 50 and 100 mg under the brand name Venclexta. The typical initial adult dose for CLL 20 mg once daily for one week with gradual dose escalation (“ramp-up”) to as much as 400 mg daily. Side effects are common and include bone marrow suppression, neutropenia, infections, fever, diarrhea, nausea and vomiting, anorexia, abdominal discomfort and fatigue. Severe side effects include pneumonia, neutropenic fever and sepsis, autoimmune hemolytic anemia, embryo-fetal toxicity and tumor lysis syndrome (for which prophylactic measures are recommended during the ramp-up period).

### Hepatotoxicity

In clinical trials in 240 patients with CLL, serum aminotransferase elevations occurred in 20% of subjects treated with venetoclax, but the elevations were generally transient, mild and not associated with jaundice or symptoms. In the preregistration trials, no cases of clinically apparent liver injury attributed to venetoclax were reported and few patients required drug discontinuation for liver test abnormalities. Since approval, venetoclax has had limited clinical use, but has not been implicated in cases of clinically apparent liver injury. Venetoclax decreases total white blood cell counts and can cause lymphopenia in addition to neutropenia. As a consequence, venetoclax may be capable of inducing immune reactions including reactivation of hepatitis B. However, instances of reactivation have not been reported, but neither has detailed information on the effects of venetoclax on hepatitis B virus levels in patients with preexisting hepatitis B or evidence of previous infection.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Venetoclax is unlikely to have direct hepatotoxic effects as dose escalation studies showed no dose related effect on liver test results. On the other hand, the immunosuppressive effects of venetoclax may cause liver related changes that could lead to viral or autoimmune reactions. Venetoclax is metabolized in the liver, largely via CYP 3A4 and is susceptible to drug-drug interactions with inhibitors or inducers of CYP 3A or in inhibitors or substrates of P-glycoprotein.

### Outcome and Management

Patients receiving venetoclax require careful monitoring largely for hematologic abnormalities and blood chemistry changes of tumor lysis syndrome. If serum aminotransferase levels rise to 5 times the upper limit of normal (ULN), therapy should be interrupted until levels fall to baseline or less than 1.5 times ULN.

Drug Class: Antineoplastic Agents, Antimetabolites

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Venetoclax – Venclexta®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Venetoclax)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Venetoclax | 1257044-40-8 | C45-H50-Cl-N7-O7-S | Venetoclax chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 04 April 2017

Abbreviations used: CLL, chronic lymphocytic leukemia; AML, acute myelogenous leukemia

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999; no mention of venetoclax).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 541-68. (Review of hepatotoxicity of hepatotoxicity of anticancer agents; does not discuss venetoclax).
Chabner BA, Bertino J, Cleary J, Ortiz T, Lane A, Supko JG, Ryan DP. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-53. (Textbook of pharmacology and therapeutics).
Khaw SL, Mérino D, Anderson MA, Glaser SP, Bouillet P, Roberts AW, Huang DC. Both leukaemic and normal peripheral B lymphoid cells are highly sensitive to the selective pharmacological inhibition of prosurvival Bcl-2 with ABT-199. Leukemia 2014; 28: 1207-15. (While CLL cells are highly sensitive to venetoclax, so are normal peripheral blood B cells, although not T cells, myeloid cells, thrombocytes or B-cell precursors). 24402163
Roberts AW, Davids MS, Pagel JM, Kahl BS, Puvvada SD, Gerecitano JF, Kipps TJ, et al. Targeting BCL2 with venetoclax in relapsed chronic lymphocytic leukemia. N Engl J Med. 2016; 374: 311-22. (Among 116 adults with CLL treated with varying doses of venetoclax, the overall response rate was 79% with complete remissions in 20%, while adverse events occurred in 99% and were serious in 83% of patients, including tumor lysis syndrome [one fatality], diarrhea, nausea, neutropenia, fatigue and fever; no mention of ALT elevations or hepatotoxicity). 26639348
Stilgenbauer S, Eichhorst B, Schetelig J, Coutre S, Seymour JF, Munir T, Puvvada SD, et al. Venetoclax in relapsed or refractory chronic lymphocytic leukaemia with 17p deletion: a multicentre, open-label, phase 2 study. Lancet Oncol 2016; 17: 768-78. (Among 107 adults with relapsed or refractory CLL [with the 17p deletion] treated with venetoclax in a dose ramp-up schedule to 400 mg daily for a median of 12 months, the overall response rate was 79% while serious adverse events occurred in 55% including neutropenia [40%], autoimmune hemolytic anemia [7%], pneumonia [7%], febrile neutropenia [5%] and no patient developed “abnormal hepatic function” except 1 who died of “liver derangement” that was considered not related to treatment). 27178240
Konopleva M, Pollyea DA, Potluri J, Chyla B, Hogdal L, Busman T, McKeegan E, et al. Efficacy and biological correlates of response in a phase II study of venetoclax monotherapy in patients with acute myelogenous leukemia. Cancer Discov 2016; 6: 1106-17. (Among 32 patients with relapsed or refractory AML treated with venetoclax, the overall response rate was 19% and adverse events occurred in all patients and were serious in 84%; no mention of ALT elevations or hepatotoxicity). 27520294
Deeks ED. Venetoclax: First global approval. Drugs 2016; 76: 979-87. (Summary of the pharmacology, clinical efficacy and safety of venetoclax). 27260335
Venetoclax (Venclexta) for chronic lymphocytic leukemia. Med Lett Drugs Ther 2016; 58 (1500): 101-2. (Concise review of the mechanism of action, clinical efficacy, safety and costs of venetoclax shortly after its approval in the US; discusses its major side effects, but does not mention ALT elevations or hepatoxicity). 27466751
Seymour JF, Ma S, Brander DM, Choi MY, Barrientos J, Davids MS, Anderson MA, et al. Venetoclax plus rituximab in relapsed or refractory chronic lymphocytic leukaemia: a phase 1b study. Lancet Oncol 2017; 18: 230-40. (Among 49 adults with relapsed or refractory CLL treated with venetoclax and monthly rituximab, the overall response rate was 86% with a complete response in 51%; adverse events were common including diarrhea, fatigue, neutropenia and infection, while ALT elevations occurred in only 2 patients which were above 5 times ULN in one). 28089635
King AC, Peterson TJ, Horvat TZ, Rodriguez M, Tang LA. Venetoclax: A first-in-class oral BCL-2 inhibitor for the management of lymphoid malignancies. Ann Pharmacother 2017; 51: 410-6. (Review of the pharmacology, clinical efficacy safety and costs of venetoclax; discusses tumor lysis syndrome and its prevention, but does not mention ALT elevations or hepatotoxicity). 28056525

## OTHER REFERENCE LINKS

1. Recent References on Venetoclax: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Venetoclax/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2. Trials on Venetoclax: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Venetoclax)